# Vitamin E

## OVERVIEW

### Introduction

Vitamin E (alpha tocopherol) is a fat soluble vitamin and potent antioxidant that is believed to be important in protecting cells from oxidative stress, regulating immune function, maintaining endothelial cell integrity, and balancing normal coagulation. There is no evidence that vitamin E, in physiologic or even super-physiologic high doses, causes liver injury or jaundice.

### Background

Vitamin E is a fat soluble vitamin known chemically as alpha-tocopherol (toe kof' er ol). Vitamin E is a potent antioxidant and is believed to be important is protecting cells from oxidative stress. Alpha tocopherol exists in 8 isomeric forms, but only one (R-R-R alpha tocopherol, “natural” vitamin E) has full antioxidant activity and is the predominant form found in nature in foods rich in vitamin E. Vitamin E is taken up my multiple cells and becomes embedded in the endoplasmic reticulum where it carries out antioxidant activity, maintaining the integrity of intracellular pathways and molecules than can be altered or inactivated by reactive oxygen radicals. Deficiency of vitamin E is rare, found largely in patients with severe fat malabsorption, with advanced liver disease or on total parenteral nutrition. Vitamin E is available in multiple forms, including tablets, capsules, oral solutions and syrups and solutions for intravenous administration (for parenteral nutrition). Most formulations are available over the counter, but many are mixed isomers of alpha tocopherol and the biologic activity of these products is unclear. The recommended daily allowance (RDA) for vitamin E is 15 mg (22 IU; 35 µmol) daily in adults and varies in children from 4 mg in neonates ages 0 to 6 months, 5 mg in infants ages 7 to 12 months, 6 mg for ages 1 to 3 years, 7 mg for ages 4 to 8 years, 11 mg for ages 9 to 13 years, to 15 mg for adolescents ages 14 years and above. Recent surveys suggest that the average American diet provides less than the RDA levels for vitamin E. An adequate blood level of vitamin E is considered 4 mg/mL. Vitamin E has been evaluated as therapy or means of prevention of many diseases including coronary artery disease, stroke, cognitive decline, macular degeneration and multiple forms of cancer, but has not been shown to have a significant effect on the incidence, morbidity or mortality of these diseases. Recently, small trials have suggested that vitamin E supplements can decrease steatosis, inflammation and cell injury in patients with nonalcoholic fatty liver disease. In doses below 1000 mg (1,500 IU; 2325 µmol) daily, vitamin E has been found to be safe and without adverse events. Patients on anticoagulant therapy may have an increase in bleeding episodes because of vitamin E’s effect on platelet aggregation.

### Hepatotoxicity

Neither normal nor excessively high intakes of vitamin E are associated with liver injury or liver test abnormalities. In long term clinical trials, serum enzyme and bilirubin elevations were no more frequent with vitamin E therapy than with placebo. Indeed, in many animal models, vitamin E is protective against hepatotoxic substances and provides antioxidant and cytoprotective activity to hepatocytes. In several randomized controlled trials, vitamin E has been found to improve serum aminotransferase elevations and liver biopsy histologic findings of steatosis, inflammation and cell injury in patients with nonalcoholic steatohepatitis (NASH). Therapy was well tolerated and no patients had significant rises in serum aminotransferase levels during treatment or worsening of the underlying liver injury. While liver histology improved including steatosis, cell injury and inflammation, therapy was associated with only slight improvements in liver fibrosis, and the role of vitamin E in the long term management of nonalcoholic fatty liver disease is not clear. However, in multiple controlled trials of vitamin E therapy there have been no reports of significant liver injury or jaundice with treatment.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

It is not clear how vitamin E might cause liver injury. Vitamin E is taken up by multiple tissues and metabolized in the liver by the cytochrome P450 system, largely by CYP 4F2 to water soluble products that are excreted in the urine.

Drug Class: Vitamins

Other Drugs in the Class: Vitamin A, Vitamin B, Vitamin C, Vitamin D, Vitamin K, Folate, Niacin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vitamin E – Generic

DRUG CLASS

Vitamins

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vitamin+E)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
alpha-Tocopherol | 59-02-9 | C29-H50-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 01 April 2025

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999; does not discuss vitamin E).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp, 631-57. (Review of hepatotoxicity of dietary supplements; does not discuss vitamins and minerals).
Traber MG. Vitamin E. In, Shils ME, Olson JA, Shike M, Ross AC, eds. Modern nutrition in health and disease. 9th ed. Baltimore: Williams & Wilkins, 1998; pp 347-62. (Textbook of nutrition).
Food and Nutrition Board, Institute of Medicine. DRI dietary reference intakes: for vitamin C, vitamin E, selenium and carotenoids. Washington DC: National Academy Press, 1998. (Reports from the Food and Nutrition Board of the Institute of Medicine on dietary reference values for vitamin E intake, replacing the previously published Recommended Dietary Allowances).
Office of Dietary Supplements. https://ods.od.nih.gov/factsheets/VitaminE-HealthProfessional/ (Fact sheet on vitamin E maintained and regularly updated by the Office of Dietary Supplements, National Institutes of Health).
Diplock AT. Safety of antioxidant vitamins and beta-carotene. Am J Clin Nutr 1995; 62 (6 Suppl): 1510S-1516S. (Review of animal and human studies of safety of vitamin E uncovered no apparent toxicity; “A dosage of ≤1000 mg/d is considered to be entirely safe and without side effects”). 7495252
Meyers DG, Maloley PA, Weeks D. Safety of antioxidant vitamins. Arch Intern Med 1996; 156: 925-35. (Review of adverse effects of vitamin E mentions that several studies have shown the safety of vitamin E, but individual reports have mentioned a variety of side effects such as thrombophlebitis, headache, dizziness, urticarial and hypertension; liver toxicity in neonates was noted with an intravenous preparation that has subsequently been withdrawn and the complication has not been seen since). 8624173
Hathcock JN, Azzi A, Blumberg J, Bray T, Dickinson A, Frei B, Jialal I, et al. Vitamins E and C are safe across a broad range of intakes. Am J Clin Nutr 2005; 81: 736-45. (Review of the safety of vitamin E: “More than 20 published clinical trials involving ≥80,000 subjects have documented the safety of vitamin E supplements”). 15817846
Lee IM, Cook NR, Gaziano JM, Gordon D, Ridker PM, Manson JE, Hennekens CH, et al. Vitamin E in the primary prevention of cardiovascular disease and cancer: the Women's Health Study: a randomized controlled trial. JAMA 2005; 294: 56-65. (Results of the Women’s Health Study of vitamin E [600 IU] vs placebo every other day for ten years in 39,876 healthy women [ages ≥45 years] found no decrease in overall mortality, stroke, cardiovascular events or cancer with vitamin E therapy, and no differences in rates of side effects except for slight increase in risk for nose bleeds). 15998891
Sesso HD, Buring JE, Christen WG, Kurth T, Belanger C, MacFadyen J, Bubes V, et al. Vitamins E and C in the prevention of cardiovascular disease in men: the Physicians' Health Study II randomized controlled trial. JAMA 2008; 300: 2123-33. (Results of the Physician’s Health Study comparing therapy with vitamin E [400 IU every other day] with vitamin C [500 mg daily] versus placebo for an average of 8 years, found no effect of vitamin E on cardiovascular events or mortality, although vitamin E was associated with increase in hemorrhage stroke). 18997197
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to vitamin E). 20949552
Sanyal AJ, Chalasani N, Kowdley KV, McCullough A, Diehl AM, Bass NM, Neuschwander-Tetri BA, et al.; NASH CRN. Pioglitazone, vitamin E, or placebo for nonalcoholic steatohepatitis. N Engl J Med 2010; 362: 1675-85. (Among 247 adults with NASH treated with pioglitazone, vitamin E [800 IU daily] or placebo for 2 years, vitamin E therapy was associated with higher rates of biochemical and histological improvements than placebo, and side effects were similar). 20427778
Lavine JE, Schwimmer JB, Van Natta ML, Molleston JP, Murray KF, Rosenthal P, Abrams SH, et al.; Nonalcoholic Steatohepatitis Clinical Research Network. Effect of vitamin E or metformin for treatment of nonalcoholic fatty liver disease in children and adolescents: the TONIC randomized controlled trial. JAMA 2011; 305: 1659-68. (Among 173 children with NASH treated with vitamin E, metformin or placebo for 2 years, vitamin E was associated with a higher rate of histological resolution of NASH and marginal higher rates of improvements in ALT levels compared to placebo; side effects were similar). 21521847
Chalasani N, Younossi Z, Lavine JE, Diehl AM, Brunt EM, Cusi K, Charlton M, et al.; American Association for the Study of Liver Diseases; American College of Gastroenterology; American Gastroenterological Association. The diagnosis and management of non-alcoholic fatty liver disease: Practice guideline by the American Association for the Study of Liver Diseases, American College of Gastroenterology, and the American Gastroenterological Association. Am J Gastroenterol 2012; 107: 811-26. (Guidelines from management of nonalcoholic fatty liver disease based upon expert opinion from 3 academic societies, recommends use of vitamin E [800 IU daily] for non-diabetic adult patients with biopsy proven NASH without cirrhosis). 22641309
Fortmann SP, Burda BU, Senger CA, Lin JS, Beil TL, O'Connor E, Whitlock EP. Vitamin, mineral, and multivitamin supplements for the primary prevention of cardiovascular disease and cancer: a systematic evidence review for the U.S. Preventive Services Task Force [Internet]. Rockville (MD): Agency for Healthcare Research and Quality (US); 2013 Nov. Available from https://www.ncbi.nlm.nih.gov/books/NBK173987/. (Systematic review of efficacy and safety of vitamin E in prevention of cardiovascular disease and cancer in 6 large, controlled trials involving 120,355 patients found associations in several studies, but none that were consistently reported).
Hoofnagle JH, Van Natta ML, Kleiner DE, Clark JM, Kowdley KV, Loomba R, Neuschwander-Tetri BA, et al.; Non-alcoholic Steatohepatitis Clinical Research Network (NASH CRN). Vitamin E and changes in serum alanine aminotransferase levels in patients with non-alcoholic steatohepatitis. Aliment Pharmacol Ther 2013; 38: 134-43. (In a randomized controlled trial therapy with vitamin E (800 IU daily) was more effective than placebo in improving serum ALT levels [48% vs 12%] and improving liver steatosis, necrosis and inflammation, but not fibrosis and these effects were independent of weight loss). 23718573
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 were attributed to niacin, but none were attributed to any other vitamin including vitamin E). 25754159
Rotman Y, Sanyal AJ. Current and upcoming pharmacotherapy for non-alcoholic fatty liver disease. Gut 2017; 66: 180-90. (Review of the many agents being evaluated as therapy for nonalcoholic steatohepatitis, their evidence for efficacy, safety and mechanisms of action; vitamin E is considered an antioxidant and has few adverse effects, but long term, higher dose therapy has been variably implicated in increased risk of cardiovascular disease, stroke and cancer; no mention of hepatotoxicity). 27646933
Miyashima Y, Shibata M, Honma Y, Matsuoka H, Hiura M, Abe S, Harada M. Severe alcoholic hepatitis effectively treated with vitamin E as an add-on to corticosteroids. Intern Med 2017; 56: 3293-7. (49 year old woman with severe acute alcoholic hepatitis failed to improve rapidly with high dose corticosteroid therapy but improved promptly upon addition of oral vitamin E [150-300 mg daily]). 29021453
Bordbar M, Shakibazad N, Fattahi M, Haghpanah S, Honar N. Effect of ursodeoxycholic acid and vitamin E in the prevention of liver injury from methotrexate in pediatric leukemia. Turk J Gastroenterol 2018; 29: 203-9. (Among 80 children with acute myelogenous leukemia being treated with methotrexate, mercaptopurine and corticosteroids who were given supplemental vitamin E, ursodiol, or both or neither, rates of liver injury were similar in all groups which led them to conclude that they “failed to prove the true benefits of supplements”). 29749328
Podszun MC, Alawad AS, Lingala S, Morris N, Huang WA, Yang S, Schoenfeld M, et al. Vitamin E treatment in NAFLD patients demonstrates that oxidative stress drives steatosis through upregulation of de-novo lipogenesis. Redox Biol 2020; 37: 101710. (Analysis of liver histology, magnetic resonance spectroscopy and serum markers in 20 patients with nonalcoholic steatohepatitis treated with variable doses of vitamin E found evidence of decrease in hepatic triglyceride accumulation and de novo lipogenesis with vitamin E therapy, which was associated with improvements in histologic features of steatosis, inflammation and ballooning degeneration). 32920226
Traber MG, Head B. Vitamin E: How much is enough, too much and why! Free Radic Biol Med. 2021;177:212-225. (Review of the structure, function, biological activity, absorption, metabolism, and beneficial as well as potentially harmful effects of vitamin E supplementation, mentions that vitamin E has a hydroxyl group at the 6^th^ position of the chromanol ring that donates its hydrogen atom, thus enabling its antioxidant activity). 34699937
EFSA Panel on Nutrition, Novel Foods and Food Allergens (NDA); Turck D, Bohn T, Castenmiller J, de Henauw S, Hirsch-Ernst KI, Knutsen HK, Maciuk A, et al. Scientific opinion on the tolerable upper intake level for vitamin E. EFSA J. 2024;22:e8953. (Expert panel report on the tolerable upper intake level of vitamin E concluded that 300 mg [approximately 450 IU] daily can be considered safe in adults, except for persons taking anticoagulants or antiplatelet medications, or with vitamin K malabsorption, the major concern with higher doses being platelet function and bleeding). 39099617
Alkhouri N, McCarthy D, Bayne AV, Blonquist T, Yurko-Mauro K, Vuppalanchi R, Lawitz E, Chalasani N. The effect of vitamin E and docosahexaenoic acid ethyl ester on metabolic dysfunction-associated steatotic liver disease (MASLD)-a randomised, double-blind, placebo-controlled, parallel-group clinical trial (PUVENAFLD). Aliment Pharmacol Ther. 2024;60:552-562. (Among 203 adults with nonalcoholic fatty liver disease treated with docosahexaenoic acid [1.89 g], vitamin E [1000 mg, racemic], or both, or placebo for 6 months, there were no differences in changes from baseline of hepatic fat, serum ALT or AST, or body weight, while 3 subjects had elevations in serum ALT and AST, but none were considered due to vitamin E). 39001559
Podszun MC, Alawad AS, Lingala S, Morris N, Huang WCA, Rotman Y. Development of subtle iron deficiency during vitamin E treatment for metabolic dysfunction-associated steatotic liver disease. J Diet Suppl. 2025;22:284-299. (Among 20 patients with nonalcoholic fatty liver disease treated with vitamin E [200, 400, or 800 IU] once daily with liver biopsy immediately before and after 4 weeks of treatment, 11 patients developed evidence of iron deficiency and 6 mild anemia during treatment, several of whom had evidence of occult gastrointestinal bleeding). 39960325
Song Y, Ni W, Zheng M, Sheng H, Wang J, Xie S, Yang Y, et al.; Chinese NAFLD Clinical Research Network (CNAFLD CRN). Vitamin E (300 mg) in the treatment of MASH: A multi-center, randomized, double-blind, placebo-controlled study. Cell Rep Med. 2025;6:101939. (Among 124 Chinese patients with nonalcoholic steatohepatitis treated with vitamin E [300 mg: 450 IU] or placebo once daily for 96 weeks, vitamin E therapy was associated with improvements in serum aminotransferase levels, liver histology, and liver stiffness in comparison to placebo, and there were no serious adverse events attributed to vitamin E). 39970876

## OTHER REFERENCE LINKS

1. Recent References on Vitamin E: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vitamin%20E/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))

2. Trials on Vitamin E: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vitamin%20E)